# Quinidine

## OVERVIEW

### Introduction

Quinidine is a natural cinchona alkaloid which has potent antiarrhythmic activity and has been used for decades in the treatment of atrial and ventricular arrhythmias. Quinidine has been associated with fever, mild jaundice and clinically apparent liver injury in up to 2% of treated patients.

### Background

Quinidine (kwin' i deen) and its stereoisomer quinine (kwye' nine) are natural cinchona alkaloids found in the powdered bark of the American cinchona tree. The bark powder was used for centuries in the prevention and therapy of malaria, but was also known to decrease heart palpitations. Quinidine was found to be the most potent of the antiarrhythmic substances extracted from the cinchona plant and was introduced into medical practice in the 1940s. Quinidine acts by depressing action potentials and is considered a myocardial depressant. It was formally approved for use in the United States in 1950 and was widely used to treat ventricular arrhythmias and to suppress the frequency of premature ventricular contractions. However, careful prospective studies demonstrated that suppression of ventricular arrhythmias can be associated with a decrease in survival and use of quinidine has fallen out of favor and now used largely for therapy of atrial flutter or fibrillation. Quinidine is also approved for intravenous use in treatment of life threatening Plasmodium falciparum malaria. Quinidine is available in multiple generic forms in tablets of 200 and 300 mg as well as in sustained release formulations and as a solution for intravenous administration. A typical maintenance dose of standard formulations in adults is 200 to 400 mg three to four times daily. Common side effects include dizziness, headache, tinnitus, blurred vision, gastrointestinal upset, diarrhea, nausea and skin rash.

### Hepatotoxicity

Chronic therapy with quinidine is associated with a low rate of serum enzyme elevations, which are usually mild, asymptomatic and self limited even without alteration in dose. In addition, there have been many reports of acute hypersensitivity reactions to quinidine that include hepatic involvement. The reactions usually arise after 1 to 2 weeks of therapy, but can appear within 24 hours of restarting quinidine or with rechallenge. The clinical features are marked by fatigue, nausea, vomiting, diffuse muscle aches, arthralgias and high fever. Blood testing at an early stage shows increases in serum aminotransferase and alkaline phosphatase levels as well as mild jaundice, which can deepen for a few days even after stopping quinidine. The pattern of serum enzymes elevations is typically cholestatic or mixed. Rash is uncommon and eosinophilia is not typical, despite the presence of other signs of hypersensitivity (fever, arthralgias). Autoantibodies are not typically found. Liver biopsies usually show mild injury and small epithelioid granulomas, as are often found in many organs during systemic hypersensitivity reactions. A similar clinical signature of liver injury occurs with quinine, an optical isomer of quinidine that is used predominantly as an antimalarial agent. In recent years, there have been few reports of liver injury attributed to quinidine, probably because it is now rarely used.

Likelihood score: A (well established cause of clinically apparent liver injury).

### Mechanism of Injury

The hepatotoxicity of quinidine is clearly due to a hypersensitivity reaction and there is no evidence for a direct hepatotoxic effect of the drug. There is likely to be a genetic predisposition to this hypersensitivity.

### Outcome and Management

The hepatotoxicity of quinidine is clearly a part of a hypersensitivity reaction and is usually mild, resolving within 1 to 4 weeks of stopping. In many instances, jaundice and liver test abnormalities may worsen for a few days after stopping, but fatalities have not been reported and recovery is usually rapid. Because of the rapidity of recovery, therapy with corticosteroids is usually best avoided. There is cross reactivity to quinine (the optical isomer of quinidine which is used as an antimalarial agent) and other exposures to quinidine should be avoided.

Drug Class: Antiarrhythmic Agents

See also: Quinine

## CASE REPORT

### Case 1. Acute hypersensitivity and cholestatic liver injury due to quinidine.

[Modified from: Koch MJ, Seeff LB, Crumley CE, Rabin L, Burns WA. Quinidine hepatitis: a report of a case and review of the literature. Gastroenterology 1976; 70: 1136-40. PubMed Citation (https://www.ncbi.nlm.nih.gov/pubmed/1269875)]

A 47 year old man developed nausea, fever and right upper quadrant pain 10 days after starting quinidine for supraventricular tachycardias. He had a history of cardiac disease and was treated with furosemide, digoxin and nitroglycerin tablets chronically. He had no history of liver disease, alcohol abuse, risk factors for liver hepatitis or previous history of drug-allergies. Physical examination revealed a temperature of 101.6 ^o^F, but normal white blood cell count and differential. Quinidine was continued and he continued to have fever. While serum bilirubin levels remained normal, ALT, AST and alkaline phosphatase levels were elevated starting a few days after the onset of fever (Table). Oral and intravenous cholangiograms were negative as were tests for hepatitis B. A liver biopsy was done which showed centrizonal hepatocellular necrosis and inflammation with prominent eosinophils suggestive of drug induced liver injury. Quinidine was stopped and the fevers and liver test abnormalities rapidly resolved. Because of recurrent arrhythmias despite use of procainamide, the patient was readmitted for a monitored rechallenge with quinidine. A day after taking four doses of quinidine (200 mg every 6 hours), he developed nausea and fever. Serum ALT levels rose from 18 to 52 U/L, while eosinophil counts, alkaline phosphatase levels and bilirubin values remained normal. Symptoms and ALT elevations resolved within two days.

#### Key Points

Medication: | Quinidine (200 mg every 6 hours)
Pattern: | Cholestatic-mixed-hepatocellular (R=1.4→12.0)
Severity: | 1+ (symptoms and enzyme elevations without jaundice)
Latency: | 10 days to symptoms
Recovery: | 1-2 weeks
Other medications: | Digoxin, furosemide, nitroglycerin

#### Laboratory Values

Days After Starting | Days After Stopping | ALT* (U/L) | Alk P* (U/L) | Bilirubin* (mg/dL) | Other
Pre | | 26 | 81 | 0.4 | Admission
10 | 0 | 40 | 90 | Normal | Fever and nausea
14 | 0 | 110 | 225
20 | 0 | 150 | 150
24 | 0 | 370 | 100 | | Liver biopsy
30 | 0 | 680 | 190 | Normal | Quinidine stopped
32 | 2 | 925 | 170
36 | 6 | 345
38 | 8 | 270 | 110
Two months later rechallenged with quinidine 200 mg every 6 hours
1 | 0 | 11
2 | 1 | 18
3 | 2 | 52 | Normal | Normal | Fever and nausea
5 | 4 | 20
Normal Values | | <40 | <103 | <1.2

* Some values estimated from Figure 1.

#### Comment

This patient developed signs of hypersensitivity to quinidine (fever) which resolved rapidly with stopping therapy. With continuation of the medication, liver test abnormalities arose that were initially cholestatic but eventually hepatocellular. The injury was mild in that there was no jaundice or hepatic synthetic dysfunction. Reexposure led to a more rapid onset of symptoms and liver test abnormalities, but they were still mild and rapidly reversible.

## PRODUCT INFORMATION

REPRESENTATIVE TRADE NAMES

Quinidine – Generic

DRUG CLASS

Antiarrhythmic Agents

COMPLETE LABELING (https://dailymed.nlm.nih.gov/dailymed/search.cfm?labeltype=all&query=Quinidine)

Product labeling at DailyMed, National Library of Medicine, NIH

## CHEMICAL FORMULA AND STRUCTURE

DRUG | CAS REGISTRY NUMBER | MOLECULAR FORMULA | STRUCTURE
Quinidine | 56-54-2 | C20-H24-N2-O2 | Chemical Structure for Quinidine

## ANNOTATED BIBLIOGRAPHY

References updated: 10 May 2018

Zimmerman HJ. Antiarrhythmics. Drugs used in cardiovascular disease. In, Zimmerman HJ. Hepatotoxicity: the adverse effects of drugs and other chemicals on the liver. 2nd ed. Philadelphia: Lippincott, 1999, pp. 642-4. (Expert review of hepatotoxicity of antiarrhythmics published in 1999; among the antiarrhythmics, only amiodarone and quinidine are common causes of hepatotoxicity; quinidine has been associated with many cases of clinically apparent, but mild liver injury usually with signs of hypersensitivity and hepatic granulomas).
De Marzio DH, Navarro VJ. Cardiovascular drugs. Hepatotoxicity of cardiovascular and antidiabetic drugs. In, Kaplowitz N, DeLeve LD, eds. Drug-induced liver disease. 3rd ed. Amsterdam: Elsevier, 2013, pp. 520-1. (Review of hepatotoxicity of cardiovascular drugs including quinidine which appears to cause immunoallergic hepatitis arising within 1-2 weeks of starting).
Sampson KJ, Kass RS. Antiarrhythmic drugs. In, Brunton LL, Chabner BA, Knollman BC, eds. Goodman & Gilman’s the pharmacological basis of therapeutics. 12th ed. New York: McGraw-Hill, 2011, pp. 815-48. (Textbook of pharmacology and therapeutics).
Colding H. Et tilfaelde af kinidinallergi med feber og leverpavirkning. [A case of quinine-allergy with fever and liver injury]. Ugeskr Laeger 1969; 131: 1657-8. (74 year old woman developed fever and fatigue 2-3 weeks after starting quinine, with rise in bilirubin [0.4 to 2.0 mg/dL], AST [0.7 to 7.3 units] and Alk P [2.2 to 10.5 units] and resolution within 1 week of stopping; positive rechallenge). 5365434
Deisseroth A, Morganroth J, Winokour S. Quinidine-induced liver disease. Ann Intern Med 1972; 77: 595-7. (77 year old woman developed fever 11 days after starting quinidine followed by increases in ALT to ~210 U/L and LDH to 310 U/L, with prompt improvement upon stopping and recurrence of fever and ALT elevations within 24 hours of rechallenge). 4642741
Winkler JW. Quinidine hepatotoxicity? Ann Intern Med 1973; 78: 460. (Letter in response to Deisseroth et al. raising the issue of role of dioctyl calcium sulfosuccinate [Surfak] in the hepatic injury; authors reply that this was unlikely). 4694908
Murphy RJ, Rymer W. Quinidine induced liver disease? Ann Intern Med 1973; 78: 460. (62 year old man with 3 episodes of fever which in retrospect was thought to be due to quinidine with AST elevations of ~135 U/L, given challenge dose and developed fever to 39.4 but no change in AST). 4694908
Chajek T, Lehrer B, Geltner D, Levij IS. Quinidine-induced granulomatous hepatitis. Ann Intern Med 1974; 81: 774-6. (69 year old man developed fever 7 days after starting quinidine [bilirubin 1.0 mg/dL, Alk P 205 U/L, AST 430 U/L], resolving within a week of stopping; rechallenge led to fever within 24 hours and rise of AST to 250 U/L, Alk P 305 U/L, biopsy showing granulomas, repeat rechallenge showing the same with biopsy before and after). 4433082
Chajek T. Quinidine and granulomatous hepatitis. Ann Intern Med 1975; 82: 282. (After 1974 article, authors saw another case: 64 year old man developed fever 12 days after starting quinidine with Alk P and AST elevations and rapid improvement on stopping and recurrence on restarting, biopsy showing granulomas). 1115455
Handler SD, Hirsch NR, Hass K, Davidson FZ. Quinidine hepatitis. Arch Intern Med 1975; 135: 871-2. (72 year old woman developed abnormal liver tests [AST 367 U/L] 7 months after starting quinidine, remaining elevated for 9 months and rising to AST 800 U/L [no jaundice and Alk P peak 110 U/L], rapid improvement with stopping and positive rechallenge to one dose with symptoms and AST rising to 110 U/L). 48362
Koch MJ, Seeff LB, Crumley CE, Rabin L, Burns WA. Quinidine hepatitis: a report of a case and review of the literature. Gastroenterology 1976; 70: 1136-40. (47 year old man developed fever and abdominal pain 10 days after starting quinidine [normal bilirubin, ALT 910 U/L, Alk K 210 U/L], resolving rapidly when quinidine was stopped, and with recurrence of symptoms and mild ALT elevation within days of rechallenge: Case 1). 1269875
Geltner D, Chajek T, Rubinger D, Levij IS. Quinidine hypersensitivity and liver involvement: a survey of 32 patients. Gastroenterology 1976; 70: 650-2. (Among 487 patients who received quinidine over a 4 year period, 32 [6.5%] developed a hypersensitivity reaction, including 10 [2%] with liver involvement with fever, Alk P and AST elevations and jaundice in half usually after 4-14 days of therapy, resolving rapidly, liver biopsies showing granulomas and focal necrosis). 1261756
Dzur JR. Letter: Quinidine hepatotoxicity. JAMA 1976; 235: 908. (Patient developed jaundice one month after starting quinidine, resolving with stopping; no details given). 946110
Rotmensch HH, Rubinstein A, Livni E, Liron M, Ilie B. [Quinidine-induced subclinical hepatitis]. Harefuah. 1980; 98: 211-2. Hebrew. (68 year old man developed fever and arthralgias within weeks of starting quinidine, liver tests were normal but liver biopsy showed small granulomas and spotty hepatocyte necrosis; fever resolved within 7 days of stopping quinidine). 6997146
Bramlet DA, Posalaky Z, Olson R. Granulomatous hepatitis as a manifestation of quinidine hypersensitivity. Arch Intern Med 1980; 140: 395-7. (64 year old woman developed fever and fatigue one month after starting quinidine [bilirubin 1.8 mg/dL, ALT 327 U/L, Alk P 105 U/L], rapid resolution and positive rechallenge in one day with fever and AST elevation, underwent 3 liver biopsies showing presence, disappearance and reappearance of small granulomas). 7362358
Tiliakos N, Waites TF. Multiform quinidine toxicity. South Med J 1981; 74: 1267-8. (39 year old man developed fever, rash and fatigue 8 days after starting quinidine [4% eosinophils, thrombocytopenia, bilirubin 4 mg/dL, AST 280 U/L, Alk P 150 U/L], resolving rapidly upon stopping quinidine). 7197395
Slezak P. Quinidine hepatotoxicity. Med J Aust. 1981; 1: 139. (58 year old man developed fever, fatigue and abdominal pain 10 days after starting quinidine, followed by jaundice [bilirubin 1.6 mg/dL, ALT 208 U/L, Alk P 1.5 times ULN]). 7219288
Karoly R, Ferenc S. [An unusual side effect of quinidine: liver damage, pneumonia]. Orv Hetil 1983; 124: 055-6. Hungarian. (59 year old man developed fever, liver injury and pneumonitis within days of starting quinidine [bilirubin 3.1 mg/dL, ALT 120 U/L, Alk P 183 U/L, 6% eosinophils]). 6634153
Urdahl P, Bjørkheim A. [Quinidine-induced hepatitis. A case report and review of the literature]. Tidsskr Nor Laegeforen 1983; 103: 760-3. Norwegian. (60 year old woman developed fever and fatigue within a week of starting quinidine [bilirubin 2.7 mg/dL, ALT 292 U/L, Alk P 229 U/L], with rapid recovery and positive rechallenge). 6879565
Katz B, Weetch M, Chopra S. Quinine-induced granulomatous hepatitis. Br Med J 1983; 286: 264-5. (65 year old woman with episodic fever, nausea and polyarthralgias during 5 months of intermittent quinine use for leg cramps, [bilirubin 0.5 mg/dL, ALT 460 U/L, Alk P 375 U/L], biopsy showing granulomas; positive rechallenge with fever and ALT rising to 480 U/L). 6402064
Nirodi NS. Quinine induced granulomatous hepatitis. Br Med J (Clin Res Ed) 1983; 286: 647. (Letter questioning the presence of granulomas in case of Katz et al [1983]). 6402190
Smally AJ. When to leave well enough alone—two cases. Hosp Pract 1985; 20: 48-9. (Two cases of quinidine hepatotoxicity: 68 year old man with nausea and fever 10 days after starting quinidine followed by jaundice [bilirubin 5.4 mg/dL, AST 168 U/L, 3-4% eosinophils], and rapid recovery upon stopping; 54 year old man with onset of fever, fatigue and headache 3 weeks after starting quinidine [ALT 121 U/L], rapid resolution upon stopping). 3918052
Tanaka N, Matsushita E, Morimoto H, Kobayashi K, Hattori N. [Toxic hepatitis induced by cardiovascular agents]. Nippon Rinsho 1985; 43: 1172-5. Japanese. (Case series of drug induced liver disease due to cardiovascular agents, including one case due to quinidine). 3900470
Knobler H, Levij IS, Gavish D, Chajek-Shaul T. Quinidine-induced hepatitis: a common and reversible hypersensitivity reaction. Arch Intern Med 1986; 146: 526-8. (Among 90 cases of drug induced liver injury seen over 10 years in one referral hospital, 33 were due to quinidine [2% of recipients] with typical signature of fever, arising within first 4 weeks of therapy, both Alk P and ALT modestly elevated, only 6 with jaundice, none fulminant, all resolved rapidly with no long term consequences; 8 rechallenged and all redeveloped fever, 6 had Alk P and AST elevations as well). 3954525
Zatuchni J. Quinidine-induced hepatitis. Arch Intern Med 1986; 146: 2077, 2081. (Letter questioning Knobler et al [1986] why quinidine was used so much in view of its questionable efficacy; reply by authors). 3767557
Pariente EA, Maitre F, Marchand JP. [Hepatitis caused by quinidine. Study of a case and review of the literature]. Gastroenterol Clin Biol 1986; 10: 255-8. French. (63 year old woman developed fatigue and jaundice 1 month after starting quinidine [bilirubin 2.2 mg/dL, ALT 109 U/L, Alk P 684 U/L], biopsy showing granulomas, rapid recovery, but she had persistent hepatomegaly and elevated Alk P in follow up). 3732735
Bourlière M, Bernuau J, Rueff B, Benhamou JP. Quinidine phenylethyl-barbiturate-induced fulminant hepatitis in a pregnant woman. A case report. J Hepatol 1988; 6: 214-6. (19 year old pregnant woman developed rash and fever one month after starting quinidine and barbiturate [bilirubin 1.6 rising to 18.8 mg/dL, ALT 296 to 800 U/L, Alk P 267 U/L, prothrombin index 13%], delivering normal baby, but subsequently developing hepatic failure and undergoing successful liver transplant). 3411101
Alix M, Mosquet B, Adrien A, Cuny G, Raffy P, Moulin M. [Cholestatic hepatitis caused by quinidine phenylethylbarbiturate, and sarcoidosis. Apropos of a case]. Therapie 1989; 44: 69. French. (68 year old woman developed jaundice 2 months after starting quinidine and a barbiturate with mild fever [bilirubin 15 mg/dL, ALT 200 U/L, Alk P 342 U/L], improved with stopping, but enzymes remained high and follow up liver biopsy suggested sarcoidosis). 2734725
Mathur S, Dooley J, Scheuer PJ. Quinine induced granulomatous hepatitis and vasculitis. BMJ 1990; 300: 613. (67 year old man developed fever, rash and polyarthralgias 2 months after starting intermittent quinine therapy for leg cramps [bilirubin 0.6 mg/dL, AST 100 U/L, Alk P 1668 U/L], granulomas on biopsy and rapid recovery upon stopping). 2108777
Punukollu RC, Kumar S, Mullen KD. Quinine hepatotoxicity: an underrecognized or rare phenomenon? Arch Intern Med 1990; 150: 1112-3. (37 year old woman developed fever, arthralgias and abdominal pain without rash 2-3 weeks after starting quinine for leg cramps [bilirubin 1.8 mg/dL, ALT 128 U/L, Alk P 327 U/L, eosinophils 6%], resolving within 1 week of stopping quinine, and subsequent positive rechallenge to one dose with fever and ALT rising to 64 U/L). 2331190
Perez JA, Stryker J, Arsura EL, Hewitt JM. Probable quinine-induced hepatotoxicity. West J Med 1994; 160: 59-60 (74 year old man developed fever, abdominal pain and jaundice one month after starting quinine for leg cramps [bilirubin 7.2 mg/dL, ALT 241 U/L, Alk P 314 U/L, ESR 65], biopsy showing granulomas and rapid resolution upon stopping). 8128710
Man-Song-Hing M, Wells G. Meta-analysis of efficacy of quinine for treatment of nocturnal leg cramps in elderly people. BMJ 1995; 10: 13-7. (Meta analysis of 107 patients from 6 clinical trials; quinine reduced number of nights with leg cramps by 27%). 7827545
Horney E, Lagerstedt C, Wadenvik H. [A case report. Thrombocytopenia and granulomatous hepatitis caused by quinine]. Lakartidningen 1996; 93: 361-4. Swedish. (58 year old man developed intermittent fevers with ALT 185 U/L, GGT 145 U/L, normal bilirubin, but thrombocytopenia; positive rechallenge). 8628066
Hou M, Horney E, Stockelberg D, Jacobsson S, Kutti J, Wadenvik H. Multiple quinine-dependent antibodies in a patient with episodic thrombocytopenia, neutropenia, lymphocytopenia, and granulomatous hepatitis. Blood 1997; 90: 4806-11. (58 year old man with recurrent, transient bouts of fever, nausea, thrombocytopenia and ALT elevations [4-6 times ULN] shown to be due to intermittent exposure to quinine, with positive rechallenge and demonstration of quinine dependent antibodies to platelets and white blood cells). 9389697
Farver DK, Lavin MN. Quinine-induced hepatotoxicity. Ann Pharmacother 1999: 33: 32-4. (57 year old woman developed fever, nausea and myalgias within 24 hours of starting quinine for leg cramps with temperature 39.5 ^o^C [bilirubin 0.7 mg/dL, ALT 184 U/L, Alk P 192 U/L], resolving within 3 weeks of stopping). 9972382
Howard MA, Hibbard AB, Terrell DR, Medina PJ, Vesely SK, George JN. Quinine allergy causing acute severe systemic illness: report of 4 patients manifesting multiple hematologic, renal, and hepatic abnormalities. Proc (Bayl Univ Med Cent) 2003; 16: 21-6. (Four women developed quinine induced thrombocytopenia with other systemic manifestations, including prominent AST [131, 992, 741 and 3735 U/L] and mild Alk P [74-170 U/L] elevations and 2 with jaundice [bilirubin 4.3 and 16.1 mg/dL], often due to inadvertent quinine use from over-the-counter pills). 16278718
Schlegel A. Factitious granulomatous hepatitis? Am J Med 2004; 116: 500-1. (35 year old woman with relapsing episodes of fever, abdominal pain and ALT elevations [1488 U/L] and biopsy showing small granulomas who finally confessed to intermittent, purposeful use of quinine). 15047046
Taylor WR, White NJ. Antimalarial drug toxicity: a review. Drug Saf 2004; 27: 25-61. (Review of toxicities and safety of antimalarials: quinine can cause a characteristic hypersensitivity reaction with liver injury). 14720085
Drugs for cardiac arrhythmias. Treat Guidel Med Lett 2007; 5: 51-8. (Concise review of drugs for arrhythmias; quinidine is rarely used mainly because of toxicity and poor tolerability, currently used as an alternative therapy for suppression of supraventricular tachycardia and atrial fibrillation; mentions granulomatous hepatitis as an adverse event). 17505408
Chalasani N, Fontana RJ, Bonkovsky HL, Watkins PB, Davern T, Serrano J, Yang H, Rochon J; Drug Induced Liver Injury Network (DILIN). Causes, clinical features, and outcomes from a prospective study of drug-induced liver injury in the United States. Gastroenterology 2008; 135: 1924-34. (Among 300 cases of drug induced liver disease in the US collected between 2004 and 2008, neither quinine nor quinidine is mentioned). 18955056
Reuben A, Koch DG, Lee WM; Acute Liver Failure Study Group. Drug-induced acute liver failure: results of a U.S. multicenter, prospective study. Hepatology 2010; 52: 2065-76. (Among 1198 patients with acute liver failure enrolled in a US prospective study between 1998 and 2007, 133 were attributed to drug induced liver injury, none of which were attributed to quinidine or quinine). 20949552
Björnsson ES, Bergmann OM, Björnsson HK, Kvaran RB, Olafsson S. Incidence, presentation and outcomes in patients with drug-induced liver injury in the general population of Iceland. Gastroenterology 2013 ; 144: 1419-25. (In a population based study of drug induced liver injury from Iceland, 96 cases were identified over a 2 year period, but none were attributed to quinidine or quinine). 23419359
Hernández N, Bessone F, Sánchez A, di Pace M, Brahm J, Zapata R, A Chirino R, et al. Profile of idiosyncratic drug induced liver injury in Latin America. An analysis of published reports. Ann Hepatol 2014; 13: 231-9. (Systematic review of literature of drug induced liver injury in Latin American countries published from 1996 to 2012 identified 176 cases, none of which were attributed to quinidine or quinine). 24552865
Chalasani N, Bonkovsky HL, Fontana R, Lee W, Stolz A, Talwalkar J, Reddy KR, et al.; United States Drug Induced Liver Injury Network. Features and outcomes of 899 patients with drug-induced liver injury: The DILIN Prospective Study. Gastroenterology 2015; 148: 1340-52.e7. (Among 899 cases of drug induced liver injury enrolled in a US prospective study between 2004 and 2013, none were attributed to quinine or quinidine). 25754159

## OTHER REFERENCE LINKS

1. Recent References on Quinidine: from PubMed.gov (https://www.ncbi.nlm.nih.gov/sites/entrez?cmd=search&db=pubmed&pubmedfilters=true&term=(Quinidine/AE)+AND+Human%5BMH%5D+AND+(drug+induced+liver+injury+OR+jaundice/CI+OR+bile+duct+diseases/CI+OR+liver/DE+OR+liver+diseases/CI)+AND+(%221900/1/1%22%5BEDat%5D%3A%222999/12/31%22%5BEDat%5D))
2. Trials on Quinidine: from ClinicalTrials.gov (https://clinicaltrials.gov/ct2/results?term=Quinidine)